# Fluoxetine

## OVERVIEW

### Introduction

Fluoxetine is a selective serotonin reuptake inhibitor (SSRI) widely used as an antidepressant. Fluoxetine therapy can be associated with transient asymptomatic elevations in serum aminotransferase levels and has been linked to rare instances of clinically apparent acute liver injury.

### Background

Fluoxetine (floo ox' e teen) is an antidepressant which was one of the first of the class of selective serotonin reuptake inhibitors (SSRIs) introduced into clinical use. By blocking the reuptake of serotonin in CNS synaptic clefts, SSRIs increase serotonin levels in the brain which is associated with their antidepressant effect. Fluoxetine was approved for use in the United States in 1987 and it became one of the most widely used antidepressant medications, more than 20 million prescriptions being written yearly. Current indications include major depressive disorders, panic and obsessive compulsive disorders, bulemia nervosa and bipolar illness in combination with other agents. Fluoxetine is available as tablets and capsules of 10, 20 and 40 mg and in an oral solution of 20 mg/5 mL, in multiple generic forms and under the brand names of Prozac and Sarafem. Fixed combinations of fluoxetine with olanzapine (Symbyax and generic forms) are also available. A long acting formulation of 90 mg of fluoxetine has been developed for once weekly dosing (Prozac weekly). The recommended dosage of standard formulations of fluoxetine in adults is 20 mg once daily, increasing to 40 mg daily if necessary and not exceeding 80 mg daily. Common side effects are drowsiness, dyspepsia, nausea, headache, increased sweating, increased appetite, weight gain and sexual dysfunction.

### Hepatotoxicity

Liver test abnormalities have been reported to occur rarely in patients on fluoxetine (less than 1%), and elevations are usually modest and usually do not require dose modification or discontinuation. Rare instances of acute, clinically apparent episodes of liver injury with marked liver enzyme elevations with or without jaundice have been reported in patients on fluoxetine. The onset of injury is usually within 2 to 12 weeks and the pattern of serum enzyme elevations is usually hepatocellular, but convincing cases of mixed and cholestatic injury have also been described. Autoimmune (autoantibodies) and immunoallergic features (rash, fever, eosinophilia) are uncommon.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which fluoxetine causes liver injury is not known. Fluoxetine is extensively metabolized by the liver, mainly via the cytochrome P450 system, and hepatotoxicity may be mediated by toxic intermediates of their metabolism.

### Outcome and Management

The serum aminotransferase elevations that occur on fluoxetine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. Rare instances of acute liver failure and chronic hepatitis have been attributed to fluoxetine therapy. Persons with intolerance to fluoxetine may have similar reactions to other SSRIs and careful monitoring is warranted if other such agents are used.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass, SNRIs/SSRIs: Citalopram, Escitalopram, Duloxetine, Fluvoxamine, Levomilnacipran, Paroxetine, Sertraline, Venlafaxine, Vilazodone, Vortioxetine

## CASE REPORT

### Case 1. Acute cholestatic hepatitis due to fluoxetine.

[Modified from: Cosme A, Barrio J, Lobo C, Gil Y, Castiella A, Arenas JI. Acute cholestasis by fluoxetine. Am J Gastroenterol 1994; 91: 2449-50. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/7877663)]

A 49 year old man with depression developed jaundice five months after starting fluoxetine (20 mg daily), sulpiride (100 mg daily) and diazepam (10 mg daily). He had no history of liver disease or jaundice, but drank an estimated 38 grams of alcohol (~3-4 drinks) daily. He was taking no other medications. Physical examination showed jaundice but no fever or rash. Laboratory testing showed bilirubin of 13.6 mg/dL (direct 11.6 mg/dL), modest elevations in serum aminotransferase levels (ALT 88 U/L; AST 188 U/L), but marked increases in alkaline phosphatase (682 U/L) and gamma glutamyl transpeptidase levels (1,560 U/L) (Table). Tests for hepatitis A, B and C were negative as were autoantibodies. Abdominal ultrasound, CT scans and ERCP showed no evidence of biliary obstruction. A liver biopsy showed intrahepatic cholestasis, mild portal inflammation, and isolated single hepatocyte necrosis. Fluoxetine was stopped, and he began to improve quickly. In follow up 40 days later, laboratory tests were normal.

#### Key Points

Medication: | Fluoxetine
Pattern: | Cholestatic (R=0.9)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 5 months
Recovery: | 1-2 months
Other medications: | Sulpiride, diazepam

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Fluoxetine taken for 5 months
5 months | 0 | 88 | 682 | 13.6 | Hospitalized
5.3 months | 10 days | 54 | 329 | 3.3 | Liver biopsy
6 months | 6 weeks | 26 | 297 | 0.7
Normal Values | | <40 | <280 | <1.2

#### Comment

The selective serotonin reuptake inhibitors (SSRIs) are some of the most commonly used prescription medications worldwide, yet reports of clinically apparent hepatic injury during their use are rare. Typically, the latency to onset is 1 to 6 months and the pattern of injury is either an acute hepatocellular or cholestatic hepatitis that is self-limited and rapidly reversed upon withdrawal of the agent. Sulpiride is substituted benzamide, an antipsychotic medication used in Europe but not available in the United States; it has not been clearly implicated in cases of drug induced liver injury. The possible role of alcohol can also not be completed excluded in this case, although the liver histology and the speed of recovery argue for fluoxetine rather than alcohol as a cause of the liver injury. When patients develop clinically apparent liver injury from an SSRI, it is not clear whether another member of this group can be substituted. A structurally unrelated substitute along with careful monitoring is perhaps prudent if antidepressant therapy is considered necessary.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fluoxetine – Generic, Prozac®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=fluoxetine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fluoxetine | 54910-89-3 | C17-H18-F3-N-O | Image of Fluoxetine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 02 February 2018

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity published in 1999; mentions that there have been at least 6 reports of acute, symptomatic hepatic injury and one case of chronic hepatitis attributed to fluoxetine).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of antidepressants; clinically apparent liver injury from the SSRIs is rare, and fluoxetine has been implicated in only a few isolated cases).
O'Donnell JM, Shelton RC. Pharmacotherapy of depression and anxiety disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 397-416. (Textbook of pharmacology and therapeutics).
Cooper GL. The safety of fluoxetine – an update. Br J Psychiatry 1988; 153: 77-86. (Pooled data on 2938 patients on fluoxetine, 599 on tricyclics and 799 on placebo and postmarketing data on over 7500 fluoxetine treated patients; AST values above 100 U/L occurred in 0.5% of patients on fluoxetine, but there were no cases of clinically apparent liver injury). 3074869
Lam KS, Blanchi A, Chavaillon JM. [Hepatitis probably secondary to the massive ingestion of fluvoxamine]. Gastroenterol Clin Biol 1988; 12: 398-9. (63 year old woman took an overdose of fluvoxamine [~1500 mg] and within 24 hours had elevations in ALT [1059 U/L], Alk P [668 U/L] and bilirubin [1.4 mg/dL], which remained high for more than a month). 3133277
Mars F, Dumas de la Roque G, Goissen P. [Acute hepatitis during treatment of fluoxetine]. Gastroenterol Clin Biol 1991; 15: 270-1. French. (38 year old woman with severe mitral insufficiency developed fever and weakness 7 months after starting fluoxetine [bilirubin normal, ALT 444 U/L], resolving within one month of stopping therapy). 2044897
Bobichon R, Bernard G, Mion F. [Acute hepatitis during treatment with fluoxetine]. Gastroenterol Clin Biol 1993; 17: 406-7. French. (54 year old woman developed abdominal pain and jaundice 9 days after starting fluoxetine [bilirubin 5.1 mg/dL, ALT 323 U/L, GGT 185 U/L], resolving in 4 weeks of stopping). 8349086
Castiella A, Arenas JI. Fluoxetine-hepatotoxicity. Am J Gastroenterol 1994; 89: 458-9. (61 year old woman developed mild, asymptomatic elevations in ALT [61 U/L] and GGT [90 U/L] one month after starting fluoxetine, resolving rapidly with stopping; no mention of Alk P or bilirubin). 8122673
Gram LF. Fluoxetine. N Engl J Med 1994; 331: 1354-62. (Review of the pharmacology, clinical indications, efficacy and safety of fluoxetine; no discussion of hepatotoxicity or ALT elevations). 7935707
Castiella A, Lopez P, Arenas JI. Fluoxetine. N Engl J Med 1994; 332: 960-1. (Letter faulting review article on fluoxetine by Gram [1994] for not mentioning hepatotoxicity). 7877663
Gram LF. Fluoxetine. N Engl J Med 1995; 332: 960-1. (Author’s reply to Castiella [1994] mentioning that there have been only 3 case reports of fluoxetine hepatotoxicity despite its use in 10-15 million patients). 787763
Friedenberg FK, Rothstein KD. Hepatitis secondary to fluoxetine treatment. Am J Psychiatry 1996; 153: 580. (57 year old man developed fatigue 2 weeks after starting fluoxetine which worsened by 10 weeks [bilirubin normal, ALT 410 U/L, Alk P normal, GGT 860 U/L], resolving within 9 days of stopping). 8599417
Cosme A, Barrio J, Lobo C, Gil Y, Castiella A, Arenas JI. Acute cholestasis by fluoxetine. Am J Gastroenterol 1996; 91: 2449-50. (49 year old man developed jaundice 5 months after starting fluoxetine [bilirubin 13.6 mg/dL, ALT 88 U/L, Alk P 682 U/L], improving within 1-2 months of stopping). 8931446
Johnston DE, Wheeler DE. Chronic hepatitis related to use of fluoxetine. Am J Gastroenterol 1997; 92: 1225-6. (35 year old man with intermittent ALT elevations [62-106 U/L], low levels of HCV RNA, ANA 1:40 and liver biopsy showing chronic hepatitis, seemingly improving with stopping fluoxetine which had been taken for 10 months). 9219808
Mourilhe P, Stokes PE. Risks and benefits of selective serotonin reuptake inhibitors in the treatment of depression. Drug Saf 1998; 18: 57-82. (Review of pharmacology, efficacy and safety of SSRIs; no mention of ALT elevations or hepatotoxicity). 9466088
Grohmann R, Rüther E, Engel RR, Hippius H. Assessment of adverse drug reactions in psychiatric inpatients with the AMSP drug safety program: methods and first results for tricyclic antidepressants and SSRI. Pharmacopsychiatry 1999; 32: 21-8. (Analysis of reporting of adverse events among inpatients in 29 German hospitals between 1993 to 1997; 896 severe adverse events were reported among 48,564 patients [1.8%], both total and hepatic events were more common with tricyclics than SSRIs). 10071179
Capella D, Bruguera M, Figueras A, Lapone R. Fluoxetine-induced hepatitis: why is postmarketing surveillance needed? Eur J Clin Pharmacol 1999; 55: 545-6. (Analysis of Spanish System of Pharmacovigilance from 1982-1999 found 6 cases of acute hepatitis due to fluoxetine, latency of 5 days to 5 months, [bilirubin 3.2-15.2 mg/dL, ALT 116-2124 U/L, Alk P 1539-2463], all cases resolving within 1-3 months of stopping). 10501826
Cai Q, Benson MA, Talbot TJ, Devadas G, Swanson HJ, Olson JL, Kirchner JP. Acute hepatitis due to fluoxetine therapy. Mayo Clin Proc 1999; 74: 692-4. (Two cases of fluoxetine hepatotoxicity; 39 year old man developed jaundice 1-2 years after starting fluoxetine [bilirubin 5.9 mg/dL, ALT 272 U/L, Alk P 153 U/L], resolving within 4-6 months of stopping; 45 year old woman with jaundice arising after 3 months of fluoxetine [bilirubin 6.4 mg/dL, ALT 641 U/L, Alk P 210 U/L], resolving within 2 months of stopping). 10405699
Shuster J. Fluoxetine and hepatitis. Nursing 2000; 30: 78. (Summary of two cases published by Cai [1999] for a nursing journal). 11249443
Carvajal García-Pando A, García del Pozo J, Sánchez AS, Velasco MA, Rueda de Castro AM, Lucena MI.Hepatotoxicity associated with the new antidepressants. J Clin Psychiatry 2002; 63: 135-7. (Analysis of cases of hepatotoxicity from antidepressants in Spanish Pharmacovigilance System from 1989-1999, identified 99 cases; among SSRIs, 26 due to fluoxetine, 14 paroxetine, 6 fluvoxamine, 5 sertraline, 3 venlafaxine and 2 citalopram; among tricyclics, 16 clomipramine 7 amitriptyline, 6 imipramine; among miscellaneous, 3 nefazodone and 1 trazodone; but all similar in rate ~1-3 per 100,000 patient-years of exposure, except for nefazodone=29/100,000). 11874214
Lucena M, Carvajal A, Andrade R, Velasco A. Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf 2003; 2: 249-62. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; SSRIs are less likely to cause injury than tricyclics and MAO inhibitors; range of presentations, typically self-limited and rapid recovery; no hallmarks of hypersensitivity). 12904104
Spigset O, Hägg S, Bate A. Hepatic injury and pancreatitis during treatment with serotonin reuptake inhibitors: data from the World Health Organization (WHO) database of adverse drug reactions. Int Clin Psychopharmacol 2003; 18:157-61. (Among 27,542 reports of hepatic injury in WHO database, 786 were related to SSRIs [3%], including citalopram 42, fluoxetine 222, fluvoxamine 54, paroxetine 191, sertraline 112, nefazodone 91 and venlafaxine 74; only nefazodone has an excess of hepatic reports in relationship to total reports). 12702895
Milkiewicz P, Chilton AP, Hubscher SG, Elias E. Antidepressant induced cholestasis: hepatocellular redistribution of multidrug resistant protein (MRP2). Gut 2003; 52: 300-3. (2 cases of cholestasis on antidepressants; 30 year old woman developed jaundice 8 weeks after starting citalopram [bilirubin 4.4 mg/dL, AST 33 U/L, Alk P 637 U/L], resolving within 2 months of stopping; 63 year old man developed jaundice 3 months after starting the tricylcic antidepressant dothiepin [bilirubin 9.4 mg/dL, AST 40 U/L, Alk P 600 U/L], resolving within 3 months of stopping while on corticosteroids, later tolerating fluoxetine for 12 months but redeveloping jaundice after 2 months of paroxetine [bilirubin 15.2 mg/dL, AST 36 U/L, Alk P 544 U/L], resolving within 6 months of stopping). 12524417
Degner D, Grohmann R, Kropp S, Rüther E, Bender S, Engel RR, Schmidt LG. Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry 2004; 37 Suppl 1: S39-45. (Analysis of adverse drug reactions reported from 1993-2000 in 35 psychiatric hospitals; 0.7% of SSRI recipients had a severe adverse event; hepatic in 0.05%). 5052513
Pinzani V, Peyriere H, Hillaire-Buys D, Pageaux GP, Blayac BP, Larrey D. Specific serotonin recapture inhibitor (SSRI) antidepressants: hepatoxicity assessment in a large cohort in France. J Hepatol 2006; 44: S256. Not in PubMed (Abstract: analysis of French Pharmacovigilance data on SSRIs found 63 cases of hepatotoxicity from paroxetine, 45 fluoxetine, 30 citalopram, 18 sertraline, and 2 fluvoxamine).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 3 were attributed to paroxetine and 3 to fluoxetine with a relative risk of injury to rate of use in the population of 3.0 and 1.8, respectively). 17539979
DeSanty KP, Amabile CM. Antidepressant-induced liver injury. Ann Pharmacother 2007; 41: 1201-11. (Review of drug induced liver injury and reports of injury from MAO inhibitors, SSRIs, tricyclics and atypical agents). 17609231
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network(DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 6 were attributed to duloxetine, 3 atomoxetine, 2 fluoxetine, 2 bupropion, and 1 sertraline as single agents). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including two linked to SSRIs, 1 to fluoxetine and 1 to venlafaxine). 20949552
Park SH, Ishino R. Liver injury associated with antidepressants. Curr Drug Saf 2013; 8: 207-23. (Review of antidepressant induced liver injury). 23914755
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver iInjury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to an SSRI despite the fact that 5 SSRIs ranked among the top 30 most prescribed drugs in Iceland). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to fluoxetine or other SSRIs). 24552865
Voican CS, Corruble E, Naveau S, Perlemuter G. Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry 2014; 171: 404-15. (Review of hepatotoxicity of antidepressants, mentions 6 case reports of injury from fluoxetine with latency of 2 to 12 months, variable patterns of enzyme elevations, 1 resulting in chronic injury, none fatal). 24362450
Chew AP, Lim WS, Tan KT. Donepezil-induced hepatotoxicity in an elderly adult taking fluoxetine. J Am Geriatr Soc 2014; 62: 2009-11. (A 79 year old man with depression, Alzheimer disease and cirrhosis due to hepatitis was taking high doses of fluoxetine [80 mg daily] and lamivudine and developed fatigue and anorexia with abnormal liver tests 6 weeks after starting donepezil [bilirubin 1.5 mg/dL, ALT 177 U/L, Alk P 127 U/L], which resolved within 8 weeks of stopping both and did not recur on starting sertraline and memantine). 25333550
Emslie GJ, Prakash A, Zhang Q, Pangallo BA, Bangs ME, March JS. A double-blind efficacy and safety study of duloxetine fixed doses in children and adolescents with major depressive disorder. J Child Adolesc Psychopharmacol 2014; 24: 170-9. (Among 355 children or adolescents with depression treated for 10 weeks either duloxetine, fluoxetine or placebo, none had ALT elevations above 3 times ULN and there were no liver related serious adverse events). 24815533
Emslie GJ, Wells TG, Prakash A, Zhang Q, Pangallo BA, Bangs ME, March JS. Acute and longer-term safety results from a pooled analysis of duloxetine studies for the treatment of children and adolescents with major depressive disorder. J Child Adolesc Psychopharmacol 2015; 25: 293-305. (Among 800 children or adolescents with depression treated with duloxetine, fluoxetine or placebo for 10 weeks with a 26 week active extension, only 1 patient on duloxetine and 1 on fluoxetine had an ALT elevation above 3 times ULN, both of which resolved despite continuing therapy). 25978741
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2%] were attributed to antidepressants including 5 due to SSRIs, 3 of which were due to escitalopram, 1 to sertraline and 1 to fluoxetine).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol 2016; 19. pii: pyv126. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/26721950) (Among 184,234 psychiatric inpatients from 80 hospitals, 149 cases [0.08%] of drug induced liver injury were reported, with very low rates reported for fluoxetine [0.02%: 1 of 4,682 patients exposed]).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al.; DILI-IT Study Group. Antidepressant-induced acute liver injury: a case-control study in an Italian inpatient population. Drug Saf 2018; 41: 95-102. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/28770534) (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an prospective study between 2010 and 2014, 17 had been exposed to antidepressants including 1 who received fluoxetine for 4 months [bilirubin 0.7 mg/dL, ALT 594 U/L, Alk P 202 U/L]).

## OTHER REFERENCE LINKS

1. Recent References on Fluoxetine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(fluoxetine)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Fluoxetine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=fluoxetine)